# Telmisartan

## OVERVIEW

### Introduction

Telmisartan is an angiotensin II receptor blocker used in the therapy of hypertension. Telmisartan is associated with a low rate of transient serum aminotransferase elevations, but has yet to be linked to instances of acute liver injury.

### Background

Telmisartan (tel" mi sar' tan) is an angiotensin II receptor blocker (ARB) used alone or in combination with other agents for therapy of hypertension. Telmisartan inhibits the renin-angiotensin system by blocking the angiotensin II type 1 receptor (AT1), which prevents the vasoconstriction and volume expansion induced by circulating angiotensin II which accounts for its potent antihypertensive activity. Telmisartan was approved for use in the United States for treatment of hypertension in 1998 and indications were subsequently broadened to include reduction in risk of cardiovascular events in patients unable to take ACE inhibitors for this use. Telmisartan is available in 20, 40 and 80 mg tablets in generic forms and under the trade name Micardis. The typical dose of telmisartan in adults is 40 to 80 mg once daily, and it is used long term. Telmisartan is also available in fixed combinations with hydrochlorothiazide (Micardis HCT) and amlodipine (Twynsta). Side effects are uncommon, but may include headache, dizziness, fatigue, cough, gastrointestinal upset and fetal toxicity. Many ARBs including telmisartan have been linked to rare cases of severe sprue-like enteropathy. The syndrome presents with severe diarrhea, weight loss and abdominal discomfort months to years after starting telmisartan. Intestinal biopsy shows villous flattening and atrophy similar to celiac disease. However, the diarrhea and symptoms do not improve with a gluten-free diet, but do resolve rapidly with stopping the angiotensin receptor blocker.

### Hepatotoxicity

Telmisartan has been associated with a low rate of serum aminotransferase elevations (<2%) that in controlled trials was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. No specific instances of clinically apparent acute liver injury have been reported in association with telmisartan therapy. However, most other ARBs have been implicated in rare instances of symptomatic hepatotoxicity. Typically, the onset of liver injury is within 1 to 8 weeks of starting therapy, and the serum enzyme pattern is hepatocellular with an acute hepatitis-like clinical syndrome. In some instances, cholestasis has developed which can be prolonged and relapsing, but ARB therapy has not been associated with vanishing bile duct syndrome or chronic liver injury. Immunoallergic manifestations (rash, fever, eosinophilia) are not common, nor is autoantibody formation. In addition, serum aminotransferase elevations may accompany the enteropathy associated with ARB use, probably due to fatty liver disease caused by the diarrhea and malnutrition.

Likelihood score: E* (Unproved but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations with telmisartan is not known. Telmisartan is metabolized in the liver to a glucuronide which is excreted in the urine. Telmisartan does not appear to be metabolized by the cytochrome P450 system and has minimal drug-drug interactions.

### Outcome and Management

The instances of acute liver injury reported with ARB use have been self limited and have not resulted in acute liver failure or chronic liver injury. While corticosteroids have been used in cases of severe cholestasis due to ARBs, their efficacy has not been shown and their use is best avoided. Patients with telmisartan induced liver injury should probably avoid use of other ARBs, although cross sensitivity to liver injury among the members of this class of agents has not been shown.

References on the safety and potential hepatotoxicity of telmisartan are given in the Overview section on the angiotensin II receptor antagonists.

Drug Class: Antihypertensive Agents, Angiotensin II Receptor Antagonists

Other Drugs in the Subclass, Angiotensin II Receptor Antagonists: Azilsartan, Candesartan, Eprosartan, Irbesartan, Losartan, Olmesartan, Valsartan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Telmisartan – Micardis®

DRUG CLASS

Angiotensin II Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Telmisartan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Telmisartan | 144701-48-4 | C33-H30-N4-O2 | Chemical Structure for Telmisartan

## OTHER REFERENCE LINKS

1. Recent References on Telmisartan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Telmisartan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Telmisartan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Telmisartan)